# Disopyramide

## OVERVIEW

### Introduction

Disopyramide is an oral antiarrhythmic agent that has been in wide use for several decades. Long term disopyramide therapy is associated with a low rate of serum enzyme elevations and is a rare cause of clinically apparent acute liver injury.

### Background

Disopyramide (dye" soe pir' a mide) is a pyridine derivative and has electrophysiological effects that resemble quinidine (antiarrhythmic Class IA). Disopyramide decreases cardiac automaticity, increases refractory periods and slows conduction. Disopyramide is considered a myocardial depressant and can depress contractility. It also has anticholinergic effects. Disopyramide was approved for use in the United States in 1977, and current indications include suppression of symptomatic premature ventricular contractions and life threatening ventricular tachycardia. It is also effective in conversion as well as maintenance of normal sinus rhythm in patients with atrial fibrillation or flutter, but is not approved for this indication in the United States. Disopyramide is available in capsules of 100 and 150 mg generically and under the brand name Norpace. Extended release formulations are also available. The usual maintenance dose in adults is 400 to 800 mg daily in 2 to 4 divided doses. The most common side effects include dry mouth, urinary hesitancy, fatigue, headache, dizziness and anxiety.

### Hepatotoxicity

In clinical trials, disopyramide was associated with a low rate of serum aminotransferase and alkaline phosphatase elevations. Despite wide scale use, disopyramide has only rarely been linked to cases of clinically apparent liver injury. Two types of hepatic injury have been described. The first is an acute hepatocellular injury that arises within 1 to 3 days of starting disopyramide and resembles acute hepatic ischemia with marked early rises in serum aminotransferase levels (and LDH), with minimal increase in alkaline phosphatase and subsequent rise in serum bilirubin. The prothrombin time may be abnormal initially. The injury resolves rapidly and may relate to sudden worsening of congestive heart failure due to the myocardial depressant effects of disopyramide.

The second type of injury is a cholestatic hepatitis that arises after 1 to 3 weeks of therapy and is characterized by jaundice and pruritus, with prominent elevations in serum alkaline phosphatase and mild-to-moderate increases in serum aminotransferase levels (Case 1). This injury may be prolonged, but reported cases have been self limited. Immunoallergic and autoimmune features are rare.

Likelihood score: B (rare but likely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which disopyramide causes liver injury is not clear but the early, acute hepatocellular injury is probably caused by ischemia due to sudden worsening of heart failure. The more delayed cholestatic hepatitis attributed to disopyramide is an idiosyncratic reaction and may relate to hypersensitivity to a product of its metabolism by the cytochrome P450 system (CYP 3A4).

### Outcome and Management

The hepatic injury caused by disopyramide ranges from asymptomatic and transient serum enzyme elevations, to acute hepatic necrosis to cholestatic hepatitis. Disopyramide has not been linked to cases of acute liver failure, chronic hepatitis or vanishing bile duct syndrome. Following the cholestatic, idiosyncratic hepatic injury due to disopyramide, recurrence with reexposure is typical and should be avoided. Withdrawal of disopyramide therapy may be associated with relapse in the arrhythmia for which it is used and is often done in the hospital under careful monitoring. There is no evidence that there is cross sensitivity to hepatic injury between disopyramide and other oral antiarrhythmic agents.

Drug Class: Antiarrhythmic Agents

## CASE REPORT

### Case 1. Mild cholestatic hepatitis due to disopyramide.

[Modified from: Edmonds ME, Hayler AM. A case of intra-hepatic cholestasis after disopyramide therapy. Eur J Clin Pharmacol 1980; 18: 285-6. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/7439249)]

A 74 year old woman developed jaundice 13 days after starting disopyramide (100 mg daily) for difficult-to-control atrial fibrillation. She gave no history of liver disease, alcohol abuse or risk factors for viral hepatitis. However, she had a complex medical history which included chronic obstructive pulmonary disease, right heart failure, gout and diverticulitis. Six weeks before the onset of jaundice, she had undergone an emergency colostomy for large bowel obstruction after perforation of a sigmoid diverticulum. The surgery was carried out under general anesthesia with thiopentone, fentanyl and nitrous oxide. Postoperatively, she received several antibiotics including ampicillin, metronidazole and cefuroxime. The medications that she took chronically were digoxin (0.125 mg), furosemide (240 mg), prednisolone (3 mg/day), and allopurinol (300 mg/day). On examination, she was jaundiced but had no fever, rash or clinical evidence of heart failure. Laboratory tests showed a serum bilirubin of 2.2 mg/dL, AST 30 U/L, alkaline phosphatase 840 U/L and GGT 840 U/L (normal 4-18 U/L). These tests had been normal earlier during her prolonged hospital admission (Table). Tests for hepatitis B and serum autoantibodies were negative. Plasma levels of disopyramide had been in the normal therapeutic range. Disopyramide and the antibiotics were discontinued. Her serum bilirubin improved over the next week, but alkaline phosphatase levels rose to above 2000 U/L and then began to fall slowly. Six weeks after stopping disopyramide, all liver tests were normal.

#### Key Points

Medication: | Disopyramide (100 mg daily)
Pattern: | Cholestatic (R=0.2)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 2 weeks
Recovery: | 6 weeks
Other medications: | Ampicillin, metronidazole, cefuroxime, allopurinol, furosemide, digoxin, prednisolone, diazepam

#### Laboratory Values

Time After Starting | Time After Stopping | AST (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Comment
Pre | | | 70 | 0.6
1.5 weeks | | | 250 | 1.3
2 weeks | 0 | 30 | 840 | 2.2 | Disopyramide stopped
3 weeks | 1 week | | 2000 | 1.3
4 weeks | 2 weeks | | 900 | 1.0
5 weeks | 3 weeks | | 250 | 0.8
8 weeks | 6 weeks | | 80 | 1.0
Normal Values | | <20 | <100 | <1.2

* Values estimated from Figure 1.

#### Comment

Despite the complexity of the medical history and exposure to multiple medications, the mild cholestatic hepatitis was entirely compatible with disopyramide induced liver injury which typically arises within 1-3 weeks of starting the medication and is characterized by a mild cholestatic course. Most of the other medications (except for ampicillin and metronidazole) were continued or restarted without recurrence of jaundice or liver test abnormalities.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Disopyramide – Generic, Norpace®

DRUG CLASS

Antiarrhythmic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Disopyramide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Disopyramide | 3737-09-5 | C21-H29-N3-O | Chemical Structure for Disopyramide

## ANNOTATED BIBLIOGRAPHY

References updated: 04 January 2018

Zimmerman HJ. Antiarrhythmics. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 642-4. (Expert review of hepatotoxicity published in 1999 mentions that disopyramide has been linked to at least 10 cases of drug-induced liver disease).
De Marzio DH, Navarro VJ. Hepatotoxicity of cardiovascular and antidiabetic drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 524. (Review of hepatotoxicity of cadriovascular drugs including antiarrhythmics; disopyramide is not discussed).
Sampson KJ, Kass RS. Antiarrhythmic drugs. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 815-60. (Textbook of pharmacology and therapeutics).
Riccioni N, Bozzi L, Susini N, Roni P. Disopyramide-induced intrahepatic cholestasis. Lancet 1977; 2: 1362-3. (61 year old man developed pruritus 10 days after starting disopyramide followed by jaundice [3.0 mg/dL, ALT 410 U/L, Alk P 171 U/L, 55% eosinophils], resolving several months after stopping). 74773
Meinertz T, Langer KH, Kasper W, Just H. Disopyramide-induced intrahepatic cholestasis. Lancet 1977; 2: 828-9. (38 year old woman with recurrent atrial fibrillation developed nausea within 3 days of starting disopyramide followed by jaundice [bilirubin 5.7 mg/dL, ALT 242 U/L, Alk P 1381 U/L], resolving several months later). 71640
Koch-Weser J. Disopyramide. N Engl J Med 1979; 300: 957-62. (Review of disopyramide; mechanism of action is unclear, myocardial depressant and has anticholinergic activity which accounts for side effects of urinary retention, visual blurring, constipation and nausea; acute psychoses, cholestatic jaundice, hypoglycemia and agranulocytosis have occurred in rare patients). 431563
Tonkin AM, Joel SE, Reynolds JL. Unusual hepatocellular and cardiovascular complications of disopyramide. Chest 1980; 77:125. (74 year old male with ventricular arrhythmia developed abnormal liver enzymes 3 days after starting disopyramide [ALT 6200 U/L, Alk P 125 U/L, bilirubin 4.0 mg/dL, INR 2.6], resolving in 2 weeks). 7351137
Craxi A, Gatto G, Maringhini A, Orsini S, Pinzello G, Pagliaro L. Disopyramide and cholestasis. Ann Intern Med 1980; 93: 150-1. (2 men and 1 woman, ages 60-79 years, developed cholestatic hepatitis 10 to 15 days after starting disopyramide [bilirubin 0.9, 14.6 and 16.9 mg/dL, ALT peak 65-120 U/L, Alk P 280-300 U/L], all resolving, but two had jaundice that lasted 4 and 7 months). 7396302
Edmonds ME, Hayler AM. A case of intra-hepatic cholestasis after disopyramide therapy. Eur J Clin Pharmacol 1980; 18: 285-6. (74 year old woman developed jaundice 13 days after starting disopyramide [bilirubin 2.3 mg/dL, Alk P 840 rising to 2000 U/L, AST 30 U/L], resolving 6 weeks after stopping: Case 1). 7439249
Scheinman SJ, Poll DS, Wolfson S. Acute cardiac failure and hepatic ischemia induced by disopyramide phosphate. Yale J Biol Med 1980; 53: 361-6. (2 men, ages 61 and 62 years, developed heart failure and raised serum enzymes within 1-2 days of starting disopyramide [AST 4780 and 1495 U/L, bilirubin peak 2.1 mg/dL, Alk P normal], resolving within 7-8 days). 7222741
Doody PT. Disopyramide hepatotoxicity and disseminated intravascular coagulation. South Med J 1982; 75: 496-8. (55 year old woman developed nausea and cyanosis within 24 hours of starting disopyramide followed by confusion by day 4, ALT rising from 28 to 3090 U/L, Alk P 92 to 138 U/L, direct bilirubin to 1.6 mg/dL, protime to 40 seconds, with recovery in 10 days). 7071649
Strathman I, Schubert EN, Cohen A, Nitzberg DM. Hypoglycemia in patients receiving disopyramide phosphate. Drug Intell Clin Pharm 1983; 17: 635-8. (Analysis of 32 reports of hypoglycemia in patients on disopyramide, 14 had liver disease; studies of glucose metabolism done in volunteers demonstrated a glucose lowering effect of disopyramide). 6413187
Bakris GL, Cross PD, Hammarsten JE. Disopyramide-associated liver dysfunction. Mayo Clin Proc 1983; 58: 265-7. (61 year old man developed jaundice 21 days after starting disopyramide [bilirubin 7.7 mg/dL, Alk P 2274, ALT not given], resolving within next 3 months). 6834895
Arif M, Laidlaw JC, Oshrain C, Willis PW 3rd, Nissen CH, McDermott DJ, Smith WS, et al. A randomized, double-blind, parallel group comparison of disopyramide phosphate and quinidine in patients with cardiac arrhythmias. Angiology 1983; 34: 393-400. (124 patients with ventricular arrhythmias received disopyramide or quinidine for 8 weeks; AST elevations occurred in 3 on quinidine and 1 on disopyramide but none had symptoms or jaundice). 6408949
Antonelli D, Koltun B, Barzilay J. Acute hepatotoxic effect of disopyramide. Chest 1984; 86: 274. (46 year old developed abdominal pain 1 day after starting disopyramide [ALT 770 U/L, normal bilirubin and Alk P], resolving in 2 weeks). 6744970
Bauman JL, Gallastegui J, Strasberg B, Swiryn S, Hoff J, Welch WJ, Bauernfeind RA. Long-term therapy with disopyramide phosphate: side effects and effectiveness. Am Heart J 1986; 111: 654-60. (Among 40 patients with arrhythmias treated with disopyramide long term, most common side effects were xerostomia, constipation, blurred vision and urinary hesitancy; no mention of liver injury or ALT elevations). 3082173
Libersa C, Caron J, Pladys A, Beuscart R, Kacet S, Wajman A, Connell C, et al. Propafenone versus disopyramide: a double-blind randomized crossover trial in patients presenting chronic ventricular arrhythmias. Clin Cardiol 1987; 10: 405-10. (Ten patients with ventricular arrhythmias were treated with disopyramide vs propafenone vs placebo in a crossover study for 6 days each; no change in chemical parameters). 2440632
Jonason T, Ringqvist I, Bandh S, Nilsson G, Nilsson H, Lidell C, Bjerle P, et al. Propafenone versus disopyramide for treatment of chronic symptomatic ventricular arrhythmias. A multicenter study. Acta Med Scand 1988; 223: 515-23. (38 patients with symptomatic ventricular arrhythmias were treated with either propafenone or disopyramide for 28 days; propafenone had fewer side effects; no mention of liver injury or ALT elevations). 3291557
Roden DM. Antiarrhythmic drugs: from mechanisms to clinical practice. Heart 2000; 84: 339-46. (Overview of antiarrhythmic drugs which are separated in four classes based upon molecular target: I being sodium channel blockers; II beta blockers; III potassium channel blockers; and, IV calcium channel blockers; some agents having multiple targets). 10956304
McNamara RL, Tamariz LJ, Segal JB, Bass EB. Management of atrial fibrillation: review of the evidence for the role of pharmacologic therapy, electrical cardioversion, and echocardiography. Ann Intern Med 2003; 139: 1018-33. (Systematic review of literature on efficacy of antiarrhythmic agents for different forms of arrhythmia; disopyramide has shown efficacy for maintenance of sinus rhythm after conversion from atrial fibrillation: hepatic side effects are not discussed). 14678922
Drugs for cardiac arrhythmias. Treat Guidel Med Lett 2007; 5: 51-8. (Concise review of drugs for arrhythmias; disopyramide can aggravate heart failure and anticholinergic effects are often prominent; no mention of adverse effects on the liver). 17505408
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease collected between 2004 and 2008 in the US, none were attributed to disopyramide). 18955056
Treatment of atrial fibrillation. Treat Guidel Med Lett 2010; 8 (97): 65-70. (Concise review of efficacy and safety of drugs for atrial fibrillation; disopyramide is effective in maintaining sinus rhythm after cardioversion; side effects resemble those of anticholinergic drugs; no mention of hepatotoxicity or ALT elevations). 20733547
Camm J. Antiarrhythmic drugs for the maintenance of sinus rhythm: risks and benefits. Int J Cardiol 2012; 155: 362-71. (Review of the safety and efficacy of antiarrhythmic drugs used to maintain normal sinus rhythm; no discussion of hepatotoxicity). 21708411
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury from Latin American countries published between 1996 and 2012 identified 176 cases, but none attributed to disopyramide). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to disopyramide). 25754159
Verlinden NJ, Coons JC. Disopyramide for hypertrophic cardiomyopathy: a pragmatic reappraisal of an old drug. Pharmacotherapy 2015; 35: 1164-72. (Review of the potential role of chronic disopyramide therapy for hypertrophic cardiomyopathy based upon analyses of 3 retrospective studies in 372 patients mentions common side effects including dry mouth, urinary retention and blurred vision due to the anitcholinergic effects of disopyramide, and cardiac arrhythmias attributed to drug induced prolongation of the QTc interval; no mention of ALT elevations or hepatotoxicity). 26684556

## OTHER REFERENCE LINKS

1. Recent References on Disopyramide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Disopyramide/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Disopyramide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Disopyramide)